# Rosiglitazone

## OVERVIEW

### Introduction

Rosiglitazone is an insulin sensitizing agent and thiazolidinedione that is indicated for the treatment of type 2 diabetes. Rosiglitazone has been linked to rare instances of acute liver injury.

### Background

Rosiglitazone (roe" si gli' ta zone) an insulin sensitizing agent that improves glucose control in patients with type 2 diabetes. Like other thiazolidinediones, it is thought to act by engagement of PPAR-γ receptors which induce multiple genes involved in glucose and fatty acid metabolism. In clinical trials, rosiglitazone was found to lower blood glucose and HbA1c levels and had additive effects with the sulfonylureas and metformin. Rosiglitazone was approved for use in the United States in 1999. While the initial thiazolidinedione – troglitazone – had been associated with high rates of serum aminotransferase elevations and multiple reports of severe liver injury and death from acute liver failure, rosiglitazone was associated with a lower rate of ALT elevations and with only rare instances of clinically apparent liver injury. Rosiglitazone is approved as an adjunct to diet and exercise in the glycemic control of patients with type 2 diabetes. Rosiglitazone is available as 2 and 4 mg tablets generically and under the brand name Avandia and the usual recommended dosage is 4 to 8 mg daily in two divided doses. Rosiglitazone is used as monotherapy as well as in combination with metformin, sulfonylureas or insulin. In 2010, the FDA published a drug safety alert concerning the cardiovascular risks of rosiglitazone and the drug has been withdrawn in many countries of the world, because of these potential long term adverse effects. In the United States, it remains available but is recommended only for patients who are unable to achieve glycemic control with other diabetes medications.

### Hepatotoxicity

In contrast to troglitazone, rosiglitazone is not associated with an increased frequency of aminotransferase elevations during therapy. In clinical trials, ALT elevations above 3 times the ULN occurred in only 0.25% of patients on rosiglitazone, compared to 0.25% of placebo recipients (and 1.9% of troglitazone recipients in similar studies). In addition, clinically apparent liver injury attributed to rosiglitazone is very rare, fewer than a dozen cases having been described in the literature despite extensive use of this agent. The liver injury usually arises between 1 and 12 weeks after starting therapy (thus, a shorter latency than typically occurs with troglitazone) and all patterns of serum enzyme elevations have been described including hepatocellular, cholestatic and mixed. Allergic phenomena are rare and autoantibodies have not been typically present. Fatal instances have been reported usually in cases with a hepatocellular pattern of injury. In most instances, recovery is complete within 1 to 2 months.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of liver injury due to rosiglitazone is not known, but the general pattern and course differs somewhat from troglitazone and it is unlikely that the thiazolidinediones share a single mechanism for liver injury.

### Outcome and Management

The liver injury from rosiglitazone is usually reversed with stopping the medication. Fatal cases of rosiglitazone associated liver injury have been reported, but most cases were self-limiting. Chronic liver disease and vanishing bile duct syndrome have not been reported with rosiglitazone therapy. There is at least some degree of cross sensitivity to the liver injury caused by the different thiazolidinediones, so that patients with rosiglitazone hepatotoxicity should avoid use of pioglitazone.

References to the safety and hepatotoxicity of rosiglitazone are given together with references to pioglitazone and troglitazone in the Overview section on the Thiazolidinediones (updated June 2018).

Drug Class: Antidiabetic Agents

Other Drugs in the Subclass, Thiazolidinediones: Pioglitazone, Troglitazone

## CASE REPORT

### Case 1. Acute hepatitis after 8 days of rosiglitazone therapy.

[Modified from: Al-Salman J, Arjomand H, Kemp DG, Mittal M. Hepatocellular injury in a patient receiving rosiglitazone. A case report. Ann Intern Med 2000; 132: 121-4. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/10644273)]

A 61 year old man with diabetes was started on rosiglitazone and developed symptoms of nausea and abdominal pain within 8 days and jaundice within 2 weeks. The patient had poorly controlled diabetes for which he took sulfonylureas and metformin without adequate control. He was tried on troglitazone therapy, but it was discontinued after 8 days because of nausea and upset stomach. After failure to tolerate repaglinide because of nausea and dizziness, he was started on rosiglitazone. Eight days later he developed anorexia, nausea and abdominal pain and subsequently noted onset of dark urine and fever. His liver test results had been normal before starting rosiglitazone, but 11 days later he had marked elevations in serum aminotransferase levels and jaundice (Table). Rosiglitazone was stopped and he began to improve. Tests for hepatitis A, B and C were negative as were autoantibodies. Ultrasonography showed no evidence of gallstones or biliary tract disease. He also had chronic obstructive pulmonary disease and a remote history of alcoholism. After a week in the hospital, he was discharged. Subsequent testing showed a slow improvement in his liver tests. Serum aminotransferase levels were normal two months later.

#### Key Points

Medication: | Rosiglitazone (4 mg daily for 11 days)
Pattern: | Hepatocellular (R=12)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 8 days to nausea and abdominal pain, 11 days to jaundice
Recovery: | 2 months
Other medications: | Bronchodilators, theophylline, prednisone, zafirlukast, acetaminophen (<2 g/day), and remotely repaglinide, metformin, sulfonylureas

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | 40
11 days | 0 | 1706 | 331 | 9.6 | Rosiglitazone stopped
15 days | 4 days | 1349 | 412 | 13.8
18 days | 7 days | 1251 | 519 | 12.8 | Discharge
24 days | 2 weeks | 558 | 486 | 12.1
31 days | 3 weeks | 133 | 274 | 4.9
9 weeks | 7 weeks | 41 | 165 | 2.3
11 weeks | 10 weeks | 38 | 144 | 1.8
Normal Values | | <40 | <117 | <1.2

#### Comment

Acute hepatocellular injury without signs of allergy (fever, eosinophilia and rash) developed within 1 to 2 weeks of starting rosiglitazone. While the pattern of liver enzyme elevations and severity of injury resembles that described with troglitazone, the short latency is atypical for the other thiazolidinediones. Interestingly, the patient did not tolerate troglitazone in the past, although no liver tests were performed at the time. Thus, the rapid development of liver injury upon starting rosiglitazone may have been due to cross reactivity of the injury with troglitazone and a form of reexposure. The timing of onset and recovery make rosiglitazone a highly likely cause of this hepatic injury.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Rosiglitazone – Avandia®

DRUG CLASS

Hypoglycemic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Rosiglitazone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Rosiglitazone | 122320-73-4 | C18-H19-N3-O3-S | Rosiglitazone chemical structure

## OTHER REFERENCE LINKS

1. Recent References on Rosiglitazone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(rosiglitazone/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Rosiglitazone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=rosiglitazone)